# Lacosamide

## OVERVIEW

### Introduction

Lacosamide is an amino acid derivative with a unique anticonvulsant activity that is used in combination with other agents as therapy of partial onset seizures. Lacosamide therapy is associated with a low rate of transient serum enzyme elevations and has been linked to rare instances of clinically apparent liver injury.

### Background

Lacosamide (la koe' sa mide) is a functionalized amino acid derivative that appears to act by slow inactivation of voltage gated sodium channels in the central nervous system, which decreases the rate of neurotransmission and diminishes rapid, repetitive neuronal firing. Lacosamide was approved for use as an anticonvulsant in the United States in 2011 and current indications are for its use in partial-onset seizures in patients 4 years of age or above either alone or in combination with other anti-epileptic agents. Lacosamide is available in tablets of 50, 100, 150 and 200 mg under the brand name Vimpat. It is also available in solution as for oral (10 mg/mL) use and in an intravenous form (200 mg in single-use 20 mL vials) for short term use in adults when oral administration. The typical dose is 50 mg twice daily initially, with subsequent dose increases to an average of 200 to 400 mg daily. Side effects may include headache, dizziness, ataxia, blurred vision, nausea, fatigue and tremor.

### Hepatotoxicity

In prelicensure clinical trials, addition of lacosamide to standard anticonvulsant therapy was reported to be associated with ALT elevations above 3 times the upper limit of normal (ULN) in 7 of 935 patients (0.7%) compared to none of 356 treated with placebo. A single case of hepatitis with jaundice during lacosamide therapy was also reported. Since approval, there have been rare isolated reports of clinically apparent liver injury associated with lacosamide used, but the clinical features suggested that hepatic ischemia or other anticonvulsants combined with lacosamide may have been responsible. The onset was within a few days to several months after starting and the presentation was with a hepatocellular pattern of serum enzyme elevations, one case being asymptomatic and mild and the other severe. In both instances, there was rapid recovery.

Likelihood score: D (possible rare cause of clinically apparent liver injury)

### Mechanism of Injury

Lacosamide is metabolized by the liver, largely by CYP 2C19, 2C9 and 3A4, but has not been reported to have clinically significant drug interactions. Approximately 40% is excreted unchanged in the urine, and the metabolites of lacosamide are inactive. The mechanism of hepatic injury from lacosamide is not known, but may relate to a toxic or immunogenic metabolite.

### Outcome and Management

There is no information on the possible cross sensitivity to hepatotoxicity between lacosamide and other anticonvulsants, but its structure suggests that it would not have shared sensitivity to liver injury.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lacosamide – Vimpat®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lacosamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lacosamide | 175481-36-4 | C13-H18-N2-O3 | Lacosamide chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 March 2019

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 before the availability of lacosamide).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; lacosamide is not discussed).
Smith MD, Metcalf CS, Wilcox KS. Pharmacotherapy of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 303-326. (Textbook of pharmacology and therapeutics).
Ben-Menachem E, Biton V, Jatuzis D, Abou-Khalil B, Doty P, Rudd GD. Efficacy and safety of oral lacosamide as adjunctive therapy in adults with partial-onset seizures. Epilepsia 2007; 48: 1308-17. (Among 418 adults with poorly controlled, partial onset seizures treated with 1 of 3 doses of lacosamide or placebo for 18 weeks, there was a dose related decrease in seizure activity; 2 patients [0.5%] had ALT elevations above 3 times ULN [124 and 203 U/L], without symptoms or bilirubin elevations and both rapidly returning to normal). 17635557
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of the hepatotoxicity of anticonvulsants; no discussion of lacosamide). 18341684
Wymer JP, Simpson J, Sen D, Bongardt S; Lacosamide SP742 Study Group. Efficacy and safety of lacosamide in diabetic neuropathic pain: an 18-week double-blind placebo-controlled trial of fixed-dose regimens. Clin J Pain 2009; 25: 376-85. (Among 370 patients with diabetic neuropathy treated with placebo or 1 of 3 doses of lacosamide for 12 weeks, common side effects of dizziness, nausea, fatigue, headache and tremor were dose related and “laboratory variables were generally unremarkable”, although abnormal liver tests were recorded in some patients). 19454870
Halász P, Kälviäinen R, Mazurkiewicz-Beldzińska M, Rosenow F, Doty P, Hebert D, Sullivan T; SP755 Study Group. Adjunctive lacosamide for partial-onset seizures: Efficacy and safety results from a randomized controlled trial. Epilepsia 2009; 50: 443-53. (Among 485 patients with uncontrolled partial onset seizures who received lacosamide [200 or 400 mg daily] or placebo, side effects were more common with drug and included dizziness, diplopia, nausea, vertigo and fatigue, and no patient had an ALT elevation above 3 times ULN and a bilirubin of 2.0 concurrently). 19183227
Shaibani A, Biton V, Rauck R, Koch B, Simpson J. Long-term oral lacosamide in painful diabetic neuropathy: a two-year open-label extension trial. Eur J Pain 2009; 13: 458-63. (Among 69 patients with diabetic neuropathy treated with lacosamide [100 to 400 mg daily] for up to 2.5 years in an extension treatment trial, laboratory values overall “were generally unremarkable”). 18619874
Bauer S, David Rudd G, Mylius V, Hamer HM, Rosenow F. Lacosamide intoxication in attempted suicide. Epilepsy Behav 2010; 17: 549-51. (27 year old woman took an overdose of her anticonvulsants including 12 g of lacosamide, 56 g of gabapentin, 2 g of topiramate and 2.8 g of zonisamide with subsequent coma, rebound seizures and aspiration pneumonia, but ultimate recovery; no mention of ALT elevations or liver injury). 20171144
Chung S, Sperling MR, Biton V, Krauss G, Hebert D, Rudd GD, Doty P; SP754 Study Group. Lacosamide as adjunctive therapy for partial-onset seizures: a randomized controlled trial. Epilepsia 2010; 51: 958-67. (Among 405 patients with partial onset seizures given lacosamide or placebo as adjunctive therapy for 12 weeks, results of clinical laboratory tests did not identify "any changes that appeared to be associated with lacosamide”; 2 patients had ALT elevations above 3 times ULN, but they were transient and asymptomatic). 20132285
Ziegler D, Hidvégi T, Gurieva I, Bongardt S, Freynhagen R, Sen D, Sommerville K; Lacosamide SP743 Study Group. Efficacy and safety of lacosamide in painful diabetic neuropathy. Diabetes Care 2010; 33: 839-41. (Among 355 patients with diabetic neuropathy treated with lacosamide [400 or 600 mg daily] or placebo for 18 weeks, reduction in pain scores was greater with drug, and adverse events included dizziness, fatigue, nausea, vertigo and headache, but “changes in laboratory variables…revealed no issues of clinical concern”). 20067958
Casas-Fernández C, Martínez-Bermejo A, Rufo-Campos M, Smeyers-Durá P, Herranz-Fernández JL, Ibáñez-Micó S, Campistol-Plana J, et al. Efficacy and tolerability of lacosamide in the concomitant treatment of 130 patients under 16 years of age with refractory epilepsy: a prospective, open-label, observational, multicenter study in Spain. Drugs R D 2012; 12: 187-97. (Among 160 children [6 months to 16 years old] given adjunctive lacosamide therapy for refractory epilepsy for 3 months, “there were no alterations in conventional laboratory tests”). 23193979
Husain A, Chung S, Faught E, Isojarvi J, McShea C, Doty P. Long-term safety and efficacy in patients with uncontrolled partial-onset seizures treated with adjunctive lacosamide: results from a Phase III open-label extension trial. Epilepsia 2012; 53: 521-8. (In an open label, extension study, 208 patients were treated with lacosamide for up to 5 years; no mention of ALT elevations or hepatotoxicity and “no clinically relevant pattern of change was observed in median or mean…clinical chemistry values”). 22372628
Gutiérrez-Grobe Y, Bahena-Gonzalez JA, Herrera-Gomar M, Mendoza-Diaz P, García-López S, González-Chon O. Acute liver failure associated with levetiracetam and lacosamide combination treatment for unspecified epileptic disorder. Case Rep Emerg Med 2013; 2013: 634174. (22 year old woman developed uncontrollable seizures 2 months after starting levetiracetam and lacosamide and was admitted with acute liver failure [bilirubin 2.1 rising to 20 mg/dL, ALT 4341 U/L, Alk P 74 U/L, INR not given], with requirement for ventilator and hepatic assist support but ultimate recovery, enzymes falling to normal within 12 days; the liver injury perhaps due to hepatic ischemia from status epilepticus). 24027645
Gaitatzis A, Sander JW. The long-term safety of antiepileptic drugs. CNS Drugs 2013; 27: 435-55. (Review of the long term safety and adverse event profile of anticonvulsants mentions that valproate and felbamate can cause liver failure, but does not mention hepatotoxicity of other anticonvulsants). 23673774
Verrotti A, Loiacono G, Pizzolorusso A, Parisi P, Bruni O, Luchetti A, Zamponi N, et al. Lacosamide in pediatric and adult patients: comparison of efficacy and safety. Seizure 2013; 22: 210-6. (Among 108 patients with uncontrolled epilepsy who received with adjunctive lacosamide therapy for up to 1 year, overall results of clinical laboratory tests “did not reveal any changes associated with lacosamide treatment”). 23298605
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; lacosamide is approved as add-on therapy of adults with partial seizures; discussion of adverse effects does not mention hepatotoxicity). 23348233
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96, none were attributed to lacosamide). 23419359
Rosenfeld W, Fountain NB, Kaubrys G, Ben-Menachem E, McShea C, Isojarvi J, Doty P; SP615 Study Investigators. Safety and efficacy of adjunctive lacosamide among patients with partial-onset seizures in a long-term open-label extension trial of up to 8 years. Epilepsy Behav 2014; 41: 164-70. (Among 370 patients enrolled in a long term study [up to 8 years] of adjunctive lacosamide therapy of partial onset seizures, the safety profile was similar to that in controlled trials and therapy was not associated with changes in clinical chemistry results “that were considered clinically relevant”). 25461210
Pasha I, Kamate M, Didagi SK. Efficacy and tolerability of lacosamide as an adjunctive therapy in children with refractory partial epilepsy. Pediatr Neurol 2014; 51: 509-14. (Among 79 children with refractory seizures on adjunctive therapy with lacosamide, “overall results of clinical laboratory tests…did not reveal any changes during lacosamide treatment”). 25266613
Biton V, Gil-Nagel A, Isojarvi J, Doty P, Hebert D, Fountain NB. Safety and tolerability of lacosamide as adjunctive therapy for adults with partial-onset seizures: Analysis of data pooled from three randomized, double-blind, placebo-controlled clinical trials. Epilepsy Behav 2015; 52 (Pt A): 119-27. (Combined analysis of 1308 patients with partial onset seizures who received adjunctive therapy with lacosamide or placebo in 3 randomized controlled trials, common side effects were dizziness [31%], nausea [11%] and diplopia [11%], while ALT elevations above 3 times ULN occurred in 0.5% of lacosamide vs 0% of placebo recipients, and 4 patients were withdrawn from treatment because of liver test abnormalities, although no patient was reported as having a hepatic related serious adverse event). 26414341
Zadeh WW, Escartin A, Byrnes W, Tennigkeit F, Borghs S, Li T, Dedeken P, De Backer M; SP0954 Study Group. Efficacy and safety of lacosamide as first add-on or later adjunctive treatment for uncontrolled partial-onset seizures: A multicentre open-label trial. Seizure 2015; 31: 72-9. (Among 456 patients with uncontrolled partial onset seizures who received adjunctive lacosamide therapy for 24 weeks, no “consistent or clinically relevant effect” was seen on laboratory results). 26362380
Giráldez BG, Toledano R, García-Morales I, Gil-Nagel A, López-González FJ, Tortosa D, Ojeda J, Serratosa JM. Long-term efficacy and safety of lacosamide monotherapy in the treatment of partial-onset seizures: A multicenter evaluation. Seizure 2015; 29: 119-22. (Retrospective analysis of 66 patients with partial onset seizures treated with lacosamide alone for an average of 15 months found two-thirds were seizure free and side effects were usually mild, only 3 patients being withdrawn from treatment for side effects, none of which were related to ALT elevations or liver injury). 26076854
Sunwoo JS, Byun JI, Lee SK. A case of lacosamide-induced hepatotoxicity. Int J Clin Pharmacol Ther 2015; 53: 471-3. (22 year old woman with refractory epilepsy developed nausea and abdominal pain within a few days of adding lacosamide to her anticonvulsant regimen of zonisamide and clobazam [bilirubin normal, ALT 299 rising to 635 U/L, Alk P 169 rising to 188 U/L], with rapid recovery upon stopping lacosamide). 25907173
Baulac M, Rosenow F, Toledo M, Terada K, Li T, De Backer M, Werhahn KJ, et al. Efficacy, safety, and tolerability of lacosamide monotherapy versus controlled-release carbamazepine in patients with newly diagnosed epilepsy: a phase 3, randomised, double-blind, non-inferiority trial. Lancet Neurol 2017; 16: 43-54. (Among 888 patients with epilepse at 185 medical centers treated with titrated doses of lacosamide or controlled release carbamazepine twice daily, 74% on lacosamide and 70% on carbamazepine remained seizure free while serious adverse events arose in 7% vs 10%, withdrawal due to adverse events in 11% vs 16%, and ALT elevations in 10% vs 19%; no mention of clinically apparent hepatotoxicity although 2 patients on carbamazepine developed DRESS syndrome). 27889312
Vossler DG, Wechsler RT, Williams P, Byrnes W, Therriault S; ALEX-MT study group. Long-term exposure and safety of lacosamide monotherapy for the treatment of artial-onset (focal) seizures: Results from a multicenter, open-label trial. Epilepsia 2016; 57: 1625-33. (Among 322 patients with focal seizures treated with lacosamide, 258 for more than 1 year and 216 for 2 years, common adverse events were dizziness [27%], headache [17%] and nausea [14%] and "there was no evidence of any clinically relevant effect of lacosamide treatment on laboratory parameters"). 27528101
Vidaurre J, Gedela S, Yarosz S. Antiepileptic drugs and liver disease. Pediatr Neurol 2017; 77: 23-36. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, lacosamide being a good choice because of linear pharmacokinetics, only partial hepatic metabolism, with inactive metabolites and lack of clinically significant CYP450 interactions). 29097018
Misra UK, Dubey D, Kalita J. Comparison of lacosamide versus sodium valproate in status epilepticus: A pilot study. Epilepsy Behav 2017; 76: 110-3. (Among 66 patients wtih status epilepticus not responding to benzodiazepines treated with lacosamide or valproate intravenously, 24-hour control of seizures was more frequent with lacosamide [67% vs 46%] and adverse event rates were similar, but ALT elevations occurred only in those on valproate [n=6:18%] with peak values of 128 to 918 U/L and accompanying bilirubin elevations in two [1.8 and 3.2 mg/dL]). 28919386
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none to lacosamide). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Lacosamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lacosamide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lacosamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lacosamide)